# Antirheumatic Agents

## OVERVIEW

The term "antirheumatic drugs" refers to agents used in the therapy of inflammatory arthritis, predominantly rheumatoid arthritis, but also idiopathic juvenile arthritis, psoriatic arthritis, ankylosing spondylitis and others. Aspirin, the nonsteroidal antiinflammatory agents and corticosteroids are used commonly in these conditions, but have little effect in altering the natural history and outcomes of inflammatory arthritis, which can lead to cartilage and joint destruction and severe disability. More important and diverse are the "Disease-Modifying Anti-Rheumatic Drugs" (DMARDs) which are the mainstay of therapy in rheumatoid arthritis and have dramatically altered the outcome of these conditions, and improved the quality of life of patients with rheumatoid arthritis.

The initial DMARDs were the gold preparations which were first used in the 1930s. More potent and better tolerated agents followed in the 1950s and 1960s, including methotrexate, hydroxychloroquine, sulfasalazine, penicillamine, azathioprine and the thiopurines. More modern DMARDs have included potent, small molecule immunosuppressive agents such as leflunomide, cyclosporine, tacrolimus and mycophenolate. More recently, monoclonal antibodies and biologics have been developed that act on the primary cytokines and inflammatory pathways that are active and play a major role in rheumatoid arthritis. These important agents include the tumor necrosis factor antagonists, anticytokines (such as anakinra) and other major immunosuppressive agents (rituximab, abatacept, and tocilizumab). Agents used predominantly as antirheumatic drugs are listed below with specific links to the individual drugs. Medications for gout are given under "Antigout Agents" and nonsteroid antiinflammatory agents under "NSAIDs".

- Gold Preparations
  - Auranofin, Gold Salts, Gold Sodium Thiomalate
- Interleukin Receptor Antagonists
  - Anakinra, Canakinumab, Rilonacept, Sarilumab, Tocilizumab
- Major Immunosuppressive Agents
  - Cyclosporine, Mycophenylate, Sirolimus, Tacrolimus
- Monoclonal Antibodies
  - Adalimumab, Canakinumab, Certolizumab, Golimumab, Infliximab, Rituximab, Sarilumab, Tocilizumab, Ustekinumab
- Thiopurines
  - Azathioprine, Mercaptopurine, Thioguanine
- Tumor Necrosis Factor Antagonists
  - Adalimumab, Certolizumab, Etanercept, Golimumab, Infliximab
- Tyrosine (Janus) Kinase Inhibitors
  - Baricitinib, Tofacitinib, Upadacitinib
- Miscellaneous
  - Abatacept, Flavocoxid, Hydroxychloroquine, Leflunomide, Methotrexate, Penicillamine